# Suzetrigine

## OVERVIEW

### Introduction

Suzetrigine is an oral, selective sodium channel blocker and non-opioid analgesic that is used to treat moderate or severe pain. Suzetrigine is typically given for only a few days and has not been linked to elevations in serum aminotransferase or alkaline phosphatase levels during therapy or to episodes of clinically apparent liver injury.

### Background

Suzetrigine (soo ze’ tri geen) is a non-opioid analgesic that is used to treat moderate or severe pain such as occurs after surgery. Its mechanism of action appears to be based on selective blockage of a sodium channel Na_V_1.8 which is expressed on peripheral sensory neurons but not in the brain or spinal cord. By stabilizing the sodium channel in a closed state, suzetrigine inhibits action potentials that act as pain signals to the central nervous system. Importantly, suzetrigine has not been shown to cause addiction, dependence, sedation, or somnolence. In preregistration double blind, placebo- and active comparator-controlled trials, suzetrigine was more effective in reducing pain than placebo and similar in efficacy to standard therapy with the combination of hydrocodone and acetaminophen. Based upon these studies, suzetrigine was approved in 2025 by the FDA in the United States as therapy for moderate to severe acute pain in adults. Suzetrigine is available in tablets of 50 mg under the brand name Journavx. The recommended dose is 100 mg initially followed by 50 mg every 12 hours for the shortest duration possible for pain control and generally not to exceed 14 days. Common adverse events include mild to moderate itching, muscle spasms, rash, and increases in serum creatine phosphokinase (CPK) levels. Use of suzetrigine should be avoided in patients with advanced, decompensated liver disease (Child-Pugh C) and lower doses are recommended in patients with early decompensated disease (Child-Pugh B).

### Hepatotoxicity

In the prelicensure trials of suzetrigine, rates of serum aminotransferase elevations during suzetrigine therapy were less than 1% and were generally similar or slightly less than in patients receiving placebo or the combination of acetaminophen and hydrocodone, an active standard regimen of pain control. There were only rare ALT or AST elevations above 5 times the upper limit of normal (ULN) and no elevations of ALT or AST accompanied by jaundice or symptoms. In other uncontrolled studies of suzetrigine used for up to 14 days for both surgical and non-surgical pain, there were no instances of clinically apparent or life-threatening cases of liver injury. Since approval and clinical availability of suzetrigine, there have been no published case reports of clinically apparent liver injury, but clinical experience with its use has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Suzetrigine has not been linked to serum aminotransferase, alkaline phosphatase or bilirubin elevations during therapy although clinical experience with its use for more than a few days is limited. Suzetrigine is metabolized in the liver largely via CYP 3A4 and is susceptible to drug-drug interactions with CYP 3A4 inducers or inhibitors, concurrent administration of which should be avoided. Suzetrigine may interfere with the metabolism of other CYP 3A4 substrates and may also lower hormonal contraceptive levels.

### Outcome and Management

The product label does not recommend monitoring of liver tests before or during suzetrigine therapy. De novo appearance of liver test abnormalities or evidence of liver injury during therapy should lead to its discontinuation until the cause of the abnormalities is identified. There is no information on cross reactivity in risk for adverse events, hypersensitivity, or hepatic injury between suzetrigine and other analgesics such as acetaminophen, nonsteroid anti-inflammatory agents, or opiates.

Drug Class: Analgesics

Other agents for moderate to severe pain: Nonsteroidal Antiinflammatory Drugs (NSAIDs) (https://www.ncbi.nlm.nih.gov/books/n/livertox/NonsteroidalAntiinfl/),

Acetaminophen (https://www.ncbi.nlm.nih.gov/books/NBK548162/), Opioids, Opioid Antagonists (https://www.ncbi.nlm.nih.gov/books/n/livertox/Opioids/)

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Suzetrigine – Journavx®

DRUG CLASS

Analgesics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=f0976da4-1d20-4517-945c-b60ed2f41c12)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Suzetrigine | 2649467-58-1 | C21-H20-F5-N3-O4

## ANNOTATED BIBLIOGRAPHY

References updated: 10 May 2025

Abbreviations: ULN, upper limit of the normal range

Yaksh T, Wallace M. Opioids, analgesia, and pain management. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 355-386. (Textbook of pharmacology and therapeutics).
FDA. Integrated Review. 2025. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2025/219209Orig1s000IntegratedR.pdf (FDA review of the data on efficacy and safety of suzetrigine submitted by the sponsor in support of its approval for therapy of moderate to severe pain, mentions that in pooled analyses ALT and AST abnormalities were uncommon with suzetrigine [0.7% and 0.6%] and were less frequent than with placebo [1.1% and 0.9%], and hydrocodone with acetaminophen [2.0% and 1.8%], and that there were no cases of drug induced liver injury or concurrent rises in aminotransferase levels and bilirubin attributed to drug therapy).
Suzetrigine (Journavx) - a sodium channel blocker for acute pain. Med Lett Drugs Ther. 2025;67(1723):33-35. 40009986. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of suzetrigine shortly after its approval for therapy of adults with moderate-to-severe pain in the United States, mentions adverse events of pruritus, muscle spasms, rash, and elevations in serum CPK levels, but does not mention ALT elevations or hepatotoxicity).
Bertoch T, D'Aunno D, McCoun J, Solanki D, Taber L, Urban J, Oswald J, et al. Suzetrigine, a non-opioid Na_v_1.8 inhibitor for treatment of moderate-to-severe acute pain: Two phase 3 randomized clinical trials. Anesthesiology. 2025 Mar 21. Epub ahead of print. 40117446. (Summary of results of suzetrigine vs an active comparator arm and a placebo group in two double-blind controlled trials in adults with moderate-to-severe post-surgical pain mentions that adverse event rates were generally less frequent in the suzetrigine group in both trials [50% vs 61% and 56% in trial 1 and 31% vs 42% and 35% in trial 2] and that there were no drug-related serious adverse events; no mention of ALT elevations or hepatotoxicity). 40117446
McCoun J, Winkle P, Solanki D, Urban J, Bertoch T, Oswald J, Swisher MW, et al.; VX-548-107 Study Team. Suzetrigine, a non-opioid Na_V_1.8 inhibitor with broad applicability for moderate-to-severe acute pain: a phase 3 single-arm study for surgical or non-surgical acute pain. J Pain Res. 2025;18:1569-1576. 40165940. (Among 256 adults presenting in medical centers with either surgical [n=222] on non-surgical [p=34] moderate-to-severe pain who were treated with suzetrigine until pain resolution for up to 14 days, adverse events were generally mild to moderate and included headache, constipation, nausea, falls, and rash but led to discontinuation in only 5 patients [for accidental overdose, worsening of a pre-existing arrhythmia, nausea, rash, and somnolence], all of which were consider non-serious; no mention of ALT elevations or hepatotoxicity).
Osteen JD, Immani S, Tapley TL, Indersmitten T, Hurst NW, Healey T, Aertgeerts K, et al. Pharmacology and mechanism of action of suzetrigine, a potent and selective NAv1.8 pain signal inhibitor for the treatment of moderate to severe pain. Pain Ther. 2025;14(2):655-674. 39775738. (Description of the in vitro and in vivo activity of suzetrigine which had 31,000-fold specificity for Na_v_1.8 compared to Na_v_1.2-7, and 9 with no sedative or stimulant activity, the gene of the sodium channel [SCN10A] being expressed in peripheral sensory nerves and not in the central nervous system).

## OTHER REFERENCE LINKS

1. Recent References on Suzetrigine: from PubMed.gov (https://pubmed.ncbi.nlm.nih.gov/?term=Suzetrigine)

2. Trials on Suzetrigine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Suzetrigine)